# Antiulcer Agents

## OVERVIEW

Antiulcer agents and medications for acid peptic disease are commonly used drugs that rarely cause liver injury. Most agents act by inhibition of gastric acid production, neutralization of acid or protection of the gastrointestinal mucosa from acid injury. These agents are used for both prevention and therapy of duodenal and gastric ulcer disease as well as to alleviate acid reflux, esophagitis and minor upper intestinal discomforts.

The most commonly used antiulcer agents are antacids such as aluminium or magnesium hydroxide (Maalox, Mylanta and many others) and calcium carbonate (Tums, Rolaids and others). Antacids are minimally absorbed and have no known adverse effects on the liver. Antacid use may cause a minor rise in urinary pH and rarely the calcium salts cause hypercalcemia.

The major, most potent and effective antiulcer medications are the selective histamine type 2 receptor blockers (H2 blockers) and the proton pump inhibitors (PPIs). Both classes of antiulcer medications block the pathways of acid production or secretion, decreasing gastric acidity, improving symptoms and aiding in healing of acid-peptic diseases. These are some of the most commonly used drugs in medicine and are generally well tolerated and rarely result in serious adverse events. Nevertheless, both of these classes of agents have been linked to rare instances of acute liver injury and are discussed in LiverTox.

Other antiulcer drugs include mucosal protective agents such as sucralfate and prostaglandin analogues (misoprostol). Sucralfate (Carafate and others) is a sulfated polysaccharide that becomes a viscous polymer adhering to ulcers in mucosal surfaces and aiding in healing. Carafate is not absorbed and has not been linked to liver injury. Misoprostol is a synthetic prostaglandin E1 analogue that inhibits acid secretion and aids in ulcer healing. Misoprostol is absorbed systemically, but has not been linked to liver injury, probably because its other side effects and need for four times daily dosing limit the duration and degree of exposure.

The antiulcer agents in clinical use that are discussed in LiverTox include the following:

- Proton Pump Inhibitors
  - Dexlansoprazole
  - Esomeprazole
  - Lansoprazole
  - Omeprazole
  - Pantoprazole
  - Rabeprazole
- Selective Histamine Type 2 Receptor Antagonists/Blockers
  - Cimetidine
  - Famotidine
  - Nizatidine
  - Ranitidine

References are given in the specific drug records.